# Chaste Tree

## OVERVIEW

### Introduction

Chaste tree is an extract of the small flowering tree Vitex agnus-castus which has been used in traditional medicine for women’s health conditions including menstrual pain, premenstrual tension and infertility. Oral forms of chaste tree have not been implicated in serum aminotransferase elevations or in instances of clinically apparent liver injury.

### Background

Chaste tree is derived from fresh or dried, green, sterile shoots of the plant Vitex agnus-castus, a small flowering tree native to Asia and the Mediterranean regions but which is now widely cultivated. In the past it was believed to decrease sexual desire, for which reason it was named “chaste tree”, which is also the meaning of “agnus” (in Greek) and “castus” (in Latin). Extracts of chaste tree are prepared from the leaves, tender stems, flowers, and seeds and provided as syrup, elixir, powder, or a component of a multiingredient dietary supplement. Chemical components of chaste tree extracts include flavonoids, glycosides, organic acids, alkaloids, essential oils, diterpenoids and sterols, but its active ingredient is unknown. In traditional medicine, chaste tree has been purported to be useful for premenstrual syndrome, menstrual cramps, breast pain associated with the menstrual cycle, and infertility, but it has not been shown to be effective for any of these conditions in adequately controlled, prospective clinical trials. Chaste tree is found in multiple commercial forms including liquid extracts, powders and capsules. The recommended daily dose ranges widely, from 20 mg to 100 mg daily to as high as 1 gram three times daily. Chaste tree is generally considered to be safe and side effects are few and generally mild, but may include nausea, indigestion, abdominal discomfort, itching and headache. Rare instances of hypersensitivity reactions, skin rash and allergic dermatitis have been described.

### Hepatotoxicity

In several short term clinical trials, chaste tree in conventional oral doses was typically described as having no or only mild adverse side effects, with no mention of either hepatotoxicity or ALT elevations. Furthermore, in multiple large series of drug and herbal product induced liver injury no cases of chaste tree associated injury have been reported. Single case reports of liver injury with jaundice attributed to chaste tree have been reported to manufacturers, but other possible diagnoses were not adequately excluded. Thus, there is little evidence that chaste tree in conventional oral doses causes clinically apparent liver injury with jaundice in humans. Because of its possible hormonal effects, use of high doses in persons with preexisting liver disease or cirrhosis is discouraged, and its use is not recommended in pregnant or breastfeeding women, or in women on birth control or hormone replacement.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which chaste tree might cause liver injury is unknown. When present in multiingredient dietary supplements, the contribution of other components or toxic contaminants must be considered.

Drug Class: Herbal and Dietary Supplements

Other names: Vitex, Chaste Berry, Lilac Chaste Tree, Monk’s Pepper.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chaste tree – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/chasteberry)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chaste Tree | 91722-47-3 (https://pubchem.ncbi.nlm.nih.gov/substance/135346033) | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 20 January 2023

Abbreviations: HDS, herbal and dietary supplements.
Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not chaste tree).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of chaste tree).
Chaste Tree. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 185-7. (Compilation of short monographs on herbal medications and dietary supplements).
Lauritzen C, Reuter HD, Repges R, Böhnert KJ, Schmidt U. (1997). Treatment of premenstrual tension syndrome with Vitex agnus castus controlled, double-blind study versus pyridoxine. Phytomedicine. (Among 127 women with premenstrual tension syndrome treated with a commercial chaste tree product or pyridoxine for 3 menstrual cycles, symptom scores improved to a similar extent in both groups and adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Berger D, Schaffner W, Schrader E, Meier B, Brattström A. (2000). Efficacy of Vitex agnus castus L. extract Ze 440 in patients with pre-menstrual syndrome (PMS). Arch Gynecol Obstet. (Among 50 patients with premenstrual syndrome treated with a chaste tree extract [20 mg daily] for 3 menstrual cycles, symptom scores decreased by 42.5% and gradually returned to baseline after stopping; there were no serious adverse events and “laboratory evaluations did not reveal any relevant influence of treatment”).
Loch EG, Selle H, Boblitz N. (2000). Treatment of premenstrual syndrome with aphytopharmaceutical formulation containing Vitex agnus castus. J Womens Health Gend Based Med. (In a survey of 1643 women with premenstrual syndrome taking chaste tree supplements, most patients and providers viewed the therapy as beneficial and adverse events were reported in only 1% of subjects, most of which were mild and none were serious).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions).
Daniele C, Thompson Coon J, Pittler MH, Ernst E. (2005). Vitex agnus castus: a systematic review of adverse events. Drug Saf. (Systematic review of adverse events associated with chaste tree identified 33 studies including 5 controlled trials, postmarketing surveys, spontaneous reports to regulatory groups, and information from manufacturers, and concluded that most adverse events from chaste tree are mild and transient, most commonly nausea, headache, gastrointestinal upset, acne, pruritus and rash; along spontaneous reports was a case of Stevens Johnson syndrome and one of hepatitis with jaundice in a 39 year old woman on chaste tree from 60 days which resolved when the supplement was stopped).
Rotem C, Kaplan B. (2007). Phyto-Female Complex for the relief of hot flushes, night sweats and quality of sleep: randomized, controlled, double-blind pilot study. Gynecol Endocrinol. (Among 44 women with menopausal symptoms treated with a multiingredient supplement [black cohosh, milk thistle, red clover, ginseng and chaste tree] or placebo for 3 months, symptoms improved more with the supplement, while ALT and AST levels did not change in either group).
He Z, Chen R, Zhou Y, Geng L, Zhang Z, Chen S, Yao Y, Lu J, Lin S. (2009). Treatment for premenstrual syndrome with Vitex agnus castus: a prospective, randomized, multi-center placebo controlled study in China. Maturitas. (Among 208 women with moderate-to-severe premenstrual syndrome treated with chaste tree extract [40 mg] or placebo once daily for up to 3 cycles, symptom scores decreased more with chaste tree [from 19.2 to 6.4] than placebo [28.1 to 12.6], adverse event rates were similar [8.5% vs 7.6%] none of which were serious, and no significant differences were found in routine chemical laboratory test results).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found none attributed to chaste tree).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not chaste tree).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; chaste tree is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention chaste tree).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing chaste tree).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention chaste tree).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to chaste tree).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of the international regulatory framework for HDS products and the epidemiology, clinical presentation, diagnosis and cause of HDS associated liver injury with tables and discussion of the most commonly implicated agents, but does not include mention of chaste tree).
Depypere HT, Comhaire FH. (2014). Herbal preparations for the menopause: beyond isoflavones and black cohosh. Maturitas. (Brief review of herbal therapies for menopausal symptoms, mentions that chaste tree has not been shown to be effective for menopausal symptoms; no mention of adverse events or hepatotoxicity).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss chaste tree specifically).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss chaste tree).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while no case was attributed to chaste tree).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while chaste tree was not mentioned).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases of liver injury due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; no case was attributed to chaste tree or a vitex species).

## OTHER REFERENCE LINKS

1 Recent References on Chaste Tree: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Chaste+Tree+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Chaste Tree: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chaste%20Tree)